# Secukinumab

## OVERVIEW

### Introduction

Secukinumab is a human monoclonal antibody to interleukin-17A which acts as an immunosuppressant agent and is used to treat moderate-to-severe plaque psoriasis. Secukinumab has not been linked to serum enzyme elevations during therapy or to instances of idiosyncratic acute liver injury, but is capable of causing reactivation of hepatitis B in susceptible persons.

### Background

Secukinumab (sek" ue kin' ue mab) is a recombinant, human IgG1 monoclonal antibody to interleukin (IL)-17A, a cytokine involved in the release of proinflammatory mediators. The binding of the monoclonal antibody blocks the interaction of IL-17A with its receptor and thus decreases immune and inflammatory pathways. Secukinumab is considered an immunomodulatory agent and has been evaluated in several immune mediated diseases. In large clinical trials in severe plaque psoriasis, secukinumab was shown to be beneficial and was subsequently approved for this use in the United States in 2015. Its indications were expanded to include psoriatic arthritis and anklyosing spondylitis in 2016, scalp psoriasis in 2018 and axial spondylarthritis in 2020. Secukinumab is available in single use vials, syringes and pens of 150 mg under the brand name Cosentyx. The recommend dose varies by indication. For plaque psoriasis typical dose regimen is two 150 mg subcutaneous injections at weeks 0, 1, 2, 3 and 4 followed by every 4 weeks. Side effects are not common, but can include upper respiratory symptoms, nausea and diarrhea. Rare, but potentially severe adverse reactions include severe infections, reactivation of tuberculosis, exacerbation of Crohn disease and immediate hypersensitivity reactions.

### Hepatotoxicity

In large premarketing clinical trials of secukinumab in more than 3000 patients with psoriasis, serum enzyme elevations during therapy were no more common than with placebo and there were no instances of clinically apparent liver injury attributed to its use. Since its approval there have been no reports of idiosyncratic, clinically apparent liver injury attributed to secukinumab therapy. However, prospective studies have shown that secukinumab can induce reactivation of hepatitis B in persons with preexisting HBsAg or antibody to hepatitis B core antigen (anti-HBc). Most instances reported have been asymptomatic and mild and have arisen in persons with HBsAg in serum, generally within 1 to 6 months of starting therapy. Prophylaxis with oral antiviral agents that are active against HBV prevent reactivation have allowed use of secukinumab in patients with ongoing as well as inactive hepatitis B.

Likelihood score: E* (unlikely cause of clinically apparent liver injury, but possibly able to cause clinically apparent reactivation of hepatitis B in susceptible persons).

### Mechanism of Injury

The mechanism by which secukinumab might cause liver injury is unknown. Secukinumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity. Because of its immunomodulatory activity, secukinumab might induce an autoimmune reaction against hepatocytes, but this has yet to be shown. On the other hand, the immune effects of inhibition of IL-17 may lead to reactivation of inactive hepatitis B in a proportion of patients.

### Outcome and Management

The hepatotoxicity of secukinumab has not been shown, but its mechanism of action suggests that it might result in some instances of reactivation of hepatitis B and possibly induction of immune mediated hepatitis. Because of its potential to cause HBV reactivation, patients who are to receive secukinumab should be prescreened for HBsAg and anti-HBc. Those with HBsAg in serum should receive prophylaxis to prevent HBV reactivation using an oral nucleoside analogue with activity against HBV, such as tenofovir or entecavir. Patients without HBsAg but who have anti-HBc (with or without anti-HBs) are at low risk for significant reactivation and would be candidates for active monitoring at regular intervals for serum HBV DNA and early intervention if viral DNA appears de novo or levels increase in serum.

Other immunomodulatory biologic agents used to treat severe psoriasis include adalimumab, efalizumab, etanercept, golimumab, infliximab and ustekinumab.

Drug Class: Dermatologic Agents, Psoriasis Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Secukinumab – Cosentyx®

DRUG CLASS

Dermatologic Agents, Psoriasis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=77c4b13e-7df3-42d4-81db-3d0cddb7f67a)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Secukinumab | 1229022-83-6 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2021

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; secukinumab not specifically mentioned).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
(2003). Efalizumab (Raptiva) for treatment of psoriasis. Med Lett Drugs Ther. (Concise summary of efficacy, safety and costs of efalizumab shortly after its approval for use in psoriasis in the US; no mention of ALT elevations or hepatotoxicity).
Kaiser T, Moessner J, Patel K, McHutchison JG, Tillmann HL. (2009). Life threatening liver disease during treatment with monoclonal antibodies. BMJ. (66 year old man with psoriasis was treated with efalizumab [anti-CD11a] and then adalimumab [anti-TNF], and 11 days later developed jaundice and severe hepatitis [bilirubin 9.1 rising to 52 mg/dL, ALT 549 U/L, Alk P 131 U/L], with HBsAg being detected and slow but eventual recovery).
Aithal GP. (2011). Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol. (Analysis of spontaneous adverse event reporting of progressive PMLE in the US between 2004-2010 identified 635 cases, with higher than expected number of cases from several immunosuppressive monoclonal antibodies including efalizumab [n=12], rituximab [124] and natalizumab [123]).
Papp KA, Langley RG, Sigurgeirsson B, Abe M, Baker DR, Konno P, Haemmerle S, et al. (2013). Efficacy and safety of secukinumab in the treatment of moderate-to-severe plaque psoriasis: a randomized, double-blind, placebo-controlled phase II dose-ranging study. Br J Dermatol. (Among 125 patients with plaque psoriasis treated with one of four doses of secukinumab or placebo for 12 weeks, 1 patient was withdrawn from therapy after 9 days because of exacerbation of liver test abnormalities which were present at baseline, but few details were provided).
Rich P, Sigurgeirsson B, Thaci D, Ortonne JP, Paul C, Schopf RE, Morita A, et al. (2013). Secukinumab induction and maintenance therapy in moderate-to-severe plaque psoriasis: a randomized, double-blind, placebo-controlled, phase II regimen-finding study. Br J Dermatol. (Among 404 adult patients with plaque psoriasis treated with one of 3 dose regimens of secukinumab or placebo, common side effects were nasopharyngitis, upper respiratory infections and diarrhea; and there were “no significant shifts in clinical chemistry… parameters”).
Baeten D, Baraliakos X, Braun J, Sieper J, Emery P, van der Heijde D, McInnes I, et al. (2013). Anti-interleukin-17A monoclonal antibody secukinumab in treatment of ankylosing spondylitis: a randomised, double-blind, placebo-controlled trial. Lancet. (Among 30 patients with ankylosing spondylitis treated with secukinumab or placebo, side effects included nasopharyngitis, respiratory infections and diarrhea; no mention of ALT elevations or hepatotoxicity).
McInnes IB, Sieper J, Braun J, Emery P, van der Heijde D, Isaacs JD, Dahmen G, et al. (2014). Efficacy and safety of secukinumab, a fully human anti-interleukin-17A monoclonal antibody, in patients with moderate-to-severe psoriatic arthritis: a 24-week, randomised, double-blind, placebo-controlled, phase II proof-of-concept trial. Ann Rheum Dis. (Among 42 patients with psoriatic arthritis treated with 2 injections of secukinumab or placebo at 3 week intervals, side effects included headache, nausea, fatigue and dizziness; one patient had single, transient and mild ALT elevation 21 weeks after the last dose of secukinumab).
Genovese MC, Durez P, Richards HB, Supronik J, Dokoupilova E, Aelion JA, Lee SH, et al. (2014). One-year efficacy and safety results of secukinumab in patients with rheumatoid arthritis: phase II, dose-finding, double-blind, randomized, placebo-controlled study. J Rheumatol. (Among 237 patients with rheumatoid arthritis treated with secukinumab or placebo for 20 weeks followed by open label therapy for up to 60 weeks, adverse events were mostly mild-to-moderate, 32% of patients had infections, and there were “no notable elevations in liver enzymes or total bilirubin”).
Gisondi P, Dalle Vedove C, Girolomoni G. (2014). Efficacy and safety of secukinumab in chronic plaque psoriasis and psoriatic arthritis therapy. Dermatol Ther (Heidelb). (Review of the efficacy and safety of secukinumab in severe psoriasis mentions that the major adverse events of concern are infections, but that these are often mild and self-limited; no mention of ALT elevations or hepatotoxicity).
Langley RG, Elewski BE, Lebwohl M, Reich K, Griffiths CE, Papp K, Puig L, et al., ERASURE Study Group. (2014). FIXTURE Study Group. Secukinumab in plaque psoriasis--results of two phase 3 trials. N Engl J Med. (Among 1044 patients with plaque psoriasis treated with secukinumab or placebo in two large 52 week clinical trials, common side effects were nasopharyngitis, upper respiratory infection and diarrhea; no mention of ALT elevations or hepatotoxicity).
Paul C, Lacour JP, Tedremets L, Kreutzer K, Jazayeri S, Adams S, Guindon C, et al., JUNCTURE study group. (2015). Efficacy, safety and usability of secukinumab administration by autoinjector/pen in psoriasis: a randomized, controlled trial (JUNCTURE). J Eur Acad Dermatol Venereol. (Among 182 patients with psoriasis treated with secukinumab [150 or 300 mg by autoinjector] or placebo for 12 weeks, adverse events included nasopharyngitis, headache and pruritus, whereas injection site reactions were uncommon; no mention of ALT elevations or hepatotoxicity).
Thaçi D, Humeniuk J, Frambach Y, Bissonnette R, Goodman JJ, Shevade S, Gong Y, et al., STATURE study group. (2015). Secukinumab in psoriasis: randomized, controlled phase 3 trial results assessing the potential to improve treatment response in partial responders (STATURE). Br J Dermatol. (Among 43 patients with psoriasis and only a partial response to secukinumab at 12 weeks who were treated with standard doses or more intensive therapy intravenously, response rates after 40 weeks were similar and no new adverse reactions were identified; no mention of ALT elevations or hepatotoxicity).
Nast A, Jacobs A, Rosumeck S, Werner RN. (2015). Efficacy and safety of systemic long-term treatments for moderate-to-severe psoriasis: a systematic review and meta-analysis. J Invest Dermatol. (Systematic review of publications on the efficacy and safety of systemic therapies for psoriasis, states that there are not enough data for the selected safety outcomes for analysis of secukinumab).
McInnes IB, Mease PJ, Kirkham B, Kavanaugh A, Ritchlin CT, Rahman P, van der Heijde D, et al. (2015). FUTURE 2 Study Group. Secukinumab, a human anti-interleukin-17A monoclonal antibody, in patients with psoriatic arthritis (FUTURE 2): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. (Among 397 patients treated with 1 of 3 doses of secukinumab or placebo for at least 24 weeks, response rates were dose related and higher with secukinumab than with placebo and adverse events were largely mild-to-moderate in severity; no mention of ALT elevations or hepatotoxicity).
(2015). Drugs for psoriasis. Med Lett Drugs Ther. (Concise summary of current options for therapy of psoriasis including topical agents, phototherapy, oral systemic drugs, and biologic agents including secukinumab, mentions that serious infections occurred in 1.2% of secukinumab treated patients; no mention of hepatotoxicity).
(2015). Secukinumab (Cosentyx) for psoriasis. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of secukinumab shortly after its approval in the US mentions that urticarial and anaphylaxis have occurred with its use, but does not mention ALT elevations or hepatotoxicity).
Mease PJ, McInnes IB, Kirkham B, Kavanaugh A, Rahman P, van der Heijde D, Landewé R, et al. (2015). FUTURE 1 Study Group. Secukinumab Inhibition of Interleukin-17A in Patients with Psoriatic Arthritis. N Engl J Med. (Among 606 patients with psoriatic arthritis treated with secukinumab [75 or 150 mg] or placebo for 24 weeks, response rates were higher with secukinumab [50% and 51%] than placebo [17%], as were adverse event rates [63% vs 58%] including infections [30% vs 23%], but serious adverse event rates were similar [3.5% vs 5%]; no mention of ALT elevations or hepatotoxicity).
Baeten D, Sieper J, Braun J, Baraliakos X, Dougados M, Emery P, Deodhar A, et al. (2015). MEASURE 1 Study Group; MEASURE 2 Study Group. Secukinumab, an interleukin-17A inhibitor, in ankylosing spondylitis. N Engl J Med. (Among 590 patients with ankylosing spondylitis who received secukinumab [75 or 150 mg] or placebo in two randomized controlled trials, secukinumab was yielded higher response rates [58% and 65% with 300 mg and 52% and 40% with 75 mg] than placebo [23% and 28%], and adverse events of infections and Crohn’s disease were more frequent with secukinumab while “hepatic enzyme elevations” occurred in <1% of treated subjects).
van de Kerkhof PC, Griffiths CE, Reich K, Leonardi CL, Blauvelt A, Tsai TF, Gong Y, et al. (2016). Secukinumab long-term safety experience: A pooled analysis of 10 phase II and III clinical studies in patients with moderate to severe plaque psoriasis. J Am Acad Dermatol. (Among 3420 patients who received secukinumab in 10 placebo controlled trials, adverse event rates were 56% with secukinumab vs 50% with placebo and serious adverse events 2.2% vs 1.6%; no mention of ALT elevations or hepatotoxicity).
Pavelka K, Kivitz A, Dokoupilova E, Blanco R, Maradiaga M, Tahir H, Pricop L, et al. (2017). Efficacy, safety, and tolerability of secukinumab in patients with active ankylosing spondylitis: a randomized, double-blind phase 3 study, MEASURE 3. Arthritis Res Ther. (Among 226 patients with ankylosing spondylitis treated with secukinumab [150 or 300 mg] or placebo injections every week for 16 weeks, adverse event rates were similar in all 3 groups [45% and 46% vs 44%]; there were no discontinuations for adverse events and “no clinically relevant” changes in laboratory test results).
Bagel J, Duffin KC, Moore A, Ferris LK, Siu K, Steadman J, Kianifard F, et al. (2017). The effect of secukinumab on moderate-to-severe scalp psoriasis: Results of a 24-week, randomized, double-blind, placebo-controlled phase 3b study. J Am Acad Dermatol. (Among 102 patients with scalp psoriasis treated with secukinumab [300 mg] or placebo for 12 weeks, clinical responses were more frequent with secukinumab [53% vs 2%], but so were adverse events [73% vs 49%] including infections [29% vs 20%], but there were “no remarkable differences” in clinical chemistry results between the two groups).
Blanco FJ, Möricke R, Dokoupilova E, Codding C, Neal J, Andersson M, Rohrer S, et al. (2017). Secukinumab in active rheumatoid arthritis: a phase III randomized, double-blind, active comparator- and placebo-controlled study. Arthritis Rheumatol. (Among 551 patients with rheumatoid arthritis treated with secukinumab [75 or 150 mg] or abatacept or placebo for 24 weeks, response rates were higher with secukinumab [28% and 31%] than placebo [18%] but not abatacept [43%], although adverse event rates were similar in all groups and there were no cases of tuberculosis or deaths from liver disease).
Yanagihara S, Sugita K, Yoshida Y, Tsuruta D, Yamamoto O. (2017). Psoriasis vulgaris in a hepatitis B virus carrier successfully treated with secukinumab and entecavir combination therapy. Eur J Dermatol. (66 year old man with refractory psoriasis and HBsAg in serum [without HBV DNA] was treated for 9 months with secukinumab and given prophylaxis with entecavir and had no evidence of HBV reactivation and an excellent clinical response).
Snast I, Atzmony L, Braun M, Hodak E, Pavlovsky L. (2017). Risk for hepatitis B and C virus reactivation in patients with psoriasis on biologic therapies: A retrospective cohort study and systematic review of the literature. J Am Acad Dermatol. (Among 25 patients with psoriasis and anti-HBc without HBsAg in serum who were treated with biologic agents, including 3 treated with secukinumab, none developed serum ALT elevations or evidence of HBV reactivation).
Peccerillo F, Odorici G, Pellacani G, Conti A. (2018). Secukinumab: A positive outcome in a patient with severe psoriasis and HBV-HCV co-infection. Dermatol Ther. (42 year old man with severe psoriasis and anti-HBc without HBsAg as well as anti-HCV and HCV RNA in serum, received a 14 month course of secukinumab with marked clinical improvement and, while also receiving lamivudine, had no evidence of HBV reactivation or worsening of liver disease).
Feaster B, Cline A, Feldman SR. Secukinumab for psoriasis in a patient with hepatitis B. Dermatol Online J 2018; 24(9): 13030/qt58t2f0jh. (48 year old man with psoriasis and HBsAg in serum was successfully treated with secukinumab for two years without evidence of HBV reactivation).
Chiu HY, Hui RC, Huang YH, Huang RY, Chen KL, Tsai YC, Lai PJ, et al. (2018). Safety proﬁle of secukinumab in treatment of patients with psoriasis and concurrent hepatitis B or C: a multicentric prospective cohort study. Acta Derm Venereol. (Among 284 patients with psoriasis treated with secukinumab at 4 dermatology centers in Taiwan between 2015 and 2018, 49 had serologic evidence of hepatitis B; among 25 with HBsAg in serum, reactivation occurred in 6 of 22 [27%] not given prophylaxis, but none of 3 given prophylaxis; while among 24 with anti-HBc without HBsAg in serum, only 1 [4%] developed reactivation; but most instances were asymptomatic or mild, arose within 1-9 months of starting therapy, and did not always require antiviral therapy).
Bevans SL, Mayo TT, Elewski BE. (2018). Safety of secukinumab in hepatitis B virus. J Eur Acad Dermatol Venereol. (47 year old woman with psoriasis and chronic hepatitis B was treated with secukinumab for 14 months without evidence of reactivation; no details provided).
Baraliakos X, Braun J, Deodhar A, Poddubnyy D, Kivitz A, Tahir H, Van den Bosch F, et al. (2019). Long-term efficacy and safety of secukinumab 150 mg in ankylosing spondylitis: 5-year results from the phase III MEASURE 1 extension study. RMD Open. (Among 274 patients with ankylosing spondylitis enrolled in a long term extension study, 230 [84%] remained on secukinumab therapy for at least 5 years in whom responses were maintained and drug well tolerated; 1 patient developed herpes zoster, 1 tuberculosis, 4 died, but none from liver disease).
Reich K, Armstrong AW, Langley RG, Flavin S, Randazzo B, Li S, Hsu MC, et al. (2019). Guselkumab versus secukinumab for the treatment of moderate-to-severe psoriasis (ECLIPSE): results from a phase 3, randomized controlled trial. Lancet. (Among 1048 patients with psoriasis treated with secukinumab or guselkumab for 48 weeks, response rates were 70% vs 84% while adverse event rates were similar including serious adverse events [7% vs 6%], infections [1% vs 1%] and malignancy [1% vs 1%]; no mention of ALT elevations or hepatotoxicity).
Zhang L, Yang H, Chen Q, Zhao J. (2019). Adverse drug events observed with 150 mg versus 300 mg secukinumab for the treatment of moderate to severe plaque psoriasis: A systematic review and meta-analysis. Medicine (Baltimore). (Among 7 studies of secukinumab [either 150 or 300 mg weekly] for patients with plaque psoriasis, adverse event rates were similar for the two dose levels; no mention of ALT elevations or hepatotoxicity).
(2019). Drugs for psoriatic arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for psoriatic arthritis mentions that common adverse events from secukinumab include injection site reactions, respiratory and candida infections, nausea and diarrhea ad uncommon but severe adverse events include tuberculosis, Crohn disease and hypersensitivity reactions).
(2019). Drugs for psoriasis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for psoriasis mentions three IL-17A antagonists – secukinumab, ixekizumab and brodalumab – all of which are highly effective and relatively well tolerated; no mention of ALT elevations or hepatotoxicity).
Mease PJ, Kavanaugh A, Reimold A, Tahir H, Rech J, Hall S, Geusens P, et al. (2020). FUTURE 1 study group. Secukinumab provides sustained improvements in the signs and symptoms of psoriatic arthritis: final 5-year results from the phase 3 FUTURE 1 study. ACR Open Rheumatol. (193 of 236 patients who enrolled in a long term extension study of secukinumab remained on therapy for 5 years in whom improvements were maintained and serious adverse events were uncommon but included serious infections, Crohn disease, candida infections, cardiac events; no mention of hepatotoxicity or ALT elevations).
Moneva-Leniz LM, Sahuquillo-Torralba A, Vila-Payeras A, Mateu-Puchades A. (2020). Risk of hepatitis B virus reactivation in patients on secukinumab for psoriasis: a series of 4 cases. Actas Dermosifiliogr. (Among 4 patients identified in Spanish National Databases with psoriasis treated with secukinumab who had HBsAg [n=2] or anti-HBc without HBsAg [n=2] in serum, none developed hepatitis or evidence of reactivation of HBV during 6-30 months of treatment, two on antiviral prophylaxis and two not).
Gerdes S, Pinter A, Papavassilis C, Reinhardt M. (2020). Effects of secukinumab on metabolic and liver parameters in plaque psoriasis patients. J Eur Acad Dermatol Venereol. (In analyses of pooled data from 3 controlled trials of secukinumab and etanercept for plaque psoriasis, serum ALT and AST values were stable over 52 weeks of secukinumab therapy but not with etanercept, with which mean levels rose after 16 weeks).

## OTHER REFERENCE LINKS

1 Recent References on Secukinumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Secukinumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Secukinumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Secukinumab)